# Elagolix

## OVERVIEW

### Introduction

Elagolix is an oral, nonsteroidal gonadotropin releasing hormone (GnRH) antagonist that decreases estrogen production and is used to treat painful forms of endometriosis in women. Elagolix therapy is associated with a low rate of serum enzyme elevations during therapy and has yet to be linked to instances of clinically apparent liver injury.

### Background

Elagolix (el ag" o lix') is a synthetic nonsteroidal antagonist of gonadotropin releasing hormone (GnRH) that blocks GnRH stimulation of luteinizing hormone (LH) and follicular stimulating hormone (FSH) production by the pituitary gland, thereby decreasing the synthesis of estrogen by the ovaries in women and testosterone by the testes in men. Elagolix has been found to be palliative in women with painful endometriosis with equivalent efficacy to the GnRH agonists such as leuprolide and goserelin. Because elagolix is an antagonist of GnRH, it does not cause the initial increase in estrogen synthesis that occurs with use of GnRH agonists. Elagolix was approved for use in the United States in 2018 and current indications are limited to therapy of painful forms of endometriosis. Elagolix is available under the brand name Orilissa as tablets of 150 and 200 mg. The typical dose is either 150 once daily (low dose therapy) or 200 mg twice daily (high dose therapy). The low dose regimen is recommended for women with moderate liver dysfunction (Child-Pugh Class B cirrhosis) and elagolix is considered contraindicated in patients with more advanced cirrhosis (Class C). Common side effects include symptoms typical of hypogonadism such as hot flashes, decreased libido, anxiety, headache, nausea, diarrhea, weight gain and fluid retention. Potential severe adverse reactions include acute hypersensitivity reactions, suicidal ideation and mood disorders, and significant bone loss with extended therapy.

### Hepatotoxicity

Elagolix therapy has been associated with serum enzyme elevations in a small proportion of patients, rates of ALT elevations above 3 times the upper limit of normal being 0.2% with 150 mg once daily and 1.1% with 200 mg twice daily. The elevations, however, are generally mild and self-limited, resolving even without dose adjustment. Occasional patients require drug discontinuation because of serum enzyme elevations, but there were no instances of liver injury with jaundice or clinically apparent acute liver injury in the preregistration-controlled trials. Since its approval and more widescale use, there have been no published reports of clinically apparent liver injury attributed to elagolix.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which elagolix might cause liver injury is unknown. Elagolix has multiple complex interactions with several hepatic drug metabolizing enzymes, is a mild inducer and a substrate of CYP 3A4 and drug levels can be significantly increased by OATP1B1 and CYP 3A4 inhibitors.

### Outcome and Management

Serum aminotransferase elevations during elagolix therapy are usually mild and self-limited, rarely requiring dose adjustment or drug discontinuation. Routine monitoring of liver tests is not recommended except in patients with known, preexisting liver disease. There is no evidence of cross sensitivity to liver injury among the various GnRH antagonists.

Drug Class: Obstetrical and Gynecological Agents, Gonadotropin Releasing Hormone Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elagolix – Orilissa®

DRUG CLASS

Obstetrical and Gynecological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Elagolix)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Elagolix | 834153-87-6 | C32-H30-F5-N3-O5 | Elagolix Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 31 January 2019

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; the GnRH antagonists such as elagolix are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products; does not discuss the GnRH antagonists such as elagolix).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 20181, pp. 1237-47. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that moderate and severe liver dysfunction are associated with higher elagolix plasma levels, that serum aminotransferase elevations arise in a small proportion of patients and that there was no evidence of severe drug induced hepatotoxicity in the preregistration clinical studies).
Diamond MP, Carr B, Dmowski WP, Koltun W, O'Brien C, Jiang P, Burke J, Jimenez R, Garner E, Chwalisz K. Elagolix treatment for endometriosis-associated pain: results from a phase 2, randomized, double-blind, placebo-controlled study. Reprod Sci 2014; 21: 363-71. (Among 155 women with painful endometriosis treated with elagolix [150 or 250 mg daily] or placebo once daily for 12 weeks, pain scores decreased with elagolix treatment, but the differences from placebo were not statistically significant while adverse event rates were higher with elagolix than placebo for headache [8% and 10% vs 2%], nausea [6% and 10% vs 2%] and anxiety [6% vs 0%] as were decreases in bone mineral density measurement; no mention of ALT elevations or hepatotoxicity). 23885105
Carr B, Giudice L, Dmowski WP, O'Brien C, Jiang P, Burke J, Jimenez R, et al. Elagolix, an oral GnRH antagonist for endometriosis-associated pain: a randomized controlled study. J Endometr Pelvic Pain Disord 2013; 5: 105-15. (Among 137 women with painful endometriosis treated with elagolix or placebo for 8 weeks, reductions in pain scores were greater with elagolix while overall adverse event rates were similar; nausea, headache and hot flushes occurred in 10% of elagolix treated subjects and there were “no clinically meaningful changes in laboratory results”). 30320043
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to GnRH agonists or antagonists such as elagolix). 25754159
Taylor HS, Giudice LC, Lessey BA, Abrao MS, Kotarski J, Archer DF, Diamond MP, et al. Treatment of endometriosis-associated pain with elagolix, an oral GnRH antagonist. N Engl J Med 2017; 377: 28-40. (Among 1686 women with endometriosis and moderate-to-severe pain treated with elagolix [150 mg once or 250 mg twice daily] vs placebo for 6 months in two randomized trials, clinical responses occurred in 42% on low and 72% on high dose elagolix vs 23% on placebo, while adverse events that were more frequent with active drug included symptoms of hot flushes, headache and nausea, decreases in bone density and increases in cholesterol; no mention of ALT elevations or hepatotoxicity). 28525302
Carr BR, Stewart EA, Archer DF, Al-Hendy A, Bradley L, Watts NB, Diamond MP, et al. Elagolix alone or with add-back therapy in women with heavy menstrual bleeding and uterine leiomyomas: a randomized controlled trial. Obstet Gynecol 2018; 132: 1252-64. (Among 567 premenopausal women with heavy menstrual bleeding were treated with elagolix [300 or 600 mg daily] with or without two doses of estrogen/progestin or placebo for 6 months, menstrual bleeding decreased significantly in all groups receiving elagolix while adverse events were more with elagolix, ALT elevations above 3 times ULN occurred in 2% of subjects, but resolved in all and were not accompanied by symptoms or jaundice). 30303923
Surrey E, Taylor HS, Giudice L, Lessey BA, Abrao MS, Archer DF, Diamond MP, et al. Long-term outcomes of elagolix in women with endometriosis: results from two extension studies. Obstet Gynecol 2018; 132: 147-60. (Among 569 women with painful endometriosis who participated in randomized controlled trials of elagolix [Taylor 2017] who continued on therapy for another 6 months, response rates remained high [52% and 78%] and adverse events were similar; no mention of ALT elevations or hepatotoxicity). 29889764
Elagolix (Orilissa)--an oral GnRH antagonist for endometriosis pain. Med Lett Drugs Ther 2018; 60 (1556): 158-60. (Concise review of the mechanism of action, clinical efficacy, safety and costs of elagolix vs other treatments for endometriosis pain; mentions that aminotransferase levels rose to above 3 times ULN in 0.2% on 150 mg once daily and 1.1% on 200 mg twice daily). 30383729
Lamb YN. Elagolix: first global approval. Drugs 2018; 78: 1501-8. (Review of the history of development, mechanism of action, structure, pharmacology, clinical efficacy and side effects of elagolix; mentions that ALT elevations above 3 times ULN occurred in 0.2% on 150 mg daily, 1.1% on 200 mg twice daily and 0.1% of placebo recipients). 30194661

## OTHER REFERENCE LINKS

1. Recent References on Elagolix: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Elagolix+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Elagolix: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elagolix)